# Cystic Fibrosis Agents

## OVERVIEW

### Introduction

The “caftors” - ivacaftor, deutivacaftor, lumacaftor, tezacaftor, elexacaftor, and vanzacaftor - are orally available potentiators or correctors of the cystic fibrosis transmembrane conductance regulator (CFTR) that are used to treat patients with cystic fibrosis with specific mutations of the CFTR. Ivacaftor alone or in combination with one or two other CFTR modulators has been associated with low rate of transient serum enzyme elevations during treatment, and with uncommon episodes of symptomatic acute liver injury with or without jaundice.

### Background

Cystic fibrosis (CF) is a severe inherited disorder caused by mutations in the cystic fibrosis transmembrane conductance regulator gene (CFTR), which results in impaired clearance of mucous secretions leading to progressive pancreatic and pulmonary dysfunction, considerable disability and early mortality. CF is considered the most common, fatal genetic disorder among Caucasians, affecting 1:2,000 persons of European descent. Clinical manifestations generally arise in childhood and include pancreatic insufficiency, poor nutrition, failure to thrive, infertility, and progressive lung disease with frequent respiratory infections and pulmonary exacerbations. Survival is poor, but has improved greatly with medical interventions and attention to maintenance of rigorous pulmonary hygiene, preventive or rapid treatment of respiratory infections, and proper nutritional management. The discovery that the disease was caused by mutations in the CFTR gene led to a focused search for small molecules that might improve, correct, or potentiate CFTR function. A major problem was the diversity of mutations found in CF and the variability in how these mutations affected gene function (proper folding of the mature CFTR protein, trafficking of the protein to the proper place in the plasma membrane, channel opening, and maintenance of the open configuration). Nevertheless, several agents were identified that were potentiators or correctors ("tor") of the CFTR ("caf") and could improve respiratory function, sense of wellbeing, and nutrition, and decrease pulmonary exacerbations in patients with CF who had agent-specific mutations in the CFTR gene. Currently, six “caftors” are available clinically – ivacaftor, deutivacaftor, lumacaftor, tezacaftor, elexacaftor and vanzacaftor. Combinations of three of these modulators (“Triple Therapy”), consisting of either elexacaftor/tezacaftor/ ivacaftor (E/T/I) or vanzacaftor/tezacaftor/deutivacaftor (V/T/D) – have become the standard of care of cystic fibrosis and are effective in improving pulmonary function and symptoms in up to 85% of patients, a major milestone in management of this important genetic disease.

Ivacaftor (eye" va kaf' tor) was the first CFTR modulator to become available for use in the United States. It potentiates the opening of the CFTR channel in patients who harbor at least one mutation in the CFTR gene that is responsive to ivacaftor based upon clinical or in vitro assay data, such as the Gly551Asp (also abbreviated as G551D) CFTR mutation. Ivacaftor was approved in the United States for use in patients with the CFTR Gly551Asp mutation in 2012 and is available as monotherapy in tablets of 150 mg and as oral granules in packets of 50 and 75 mg under the brand name Kalydeco. The recommended dose in adults and children above 6 years of age is 150 mg orally every 12 hours. The dose in children less than 6 years of age is based upon body weight. The Gly551Asp mutation is found in approximately 5% of patients with CF.

Lumacaftor (loo" ma kaf' tor) is a "corrector" of the CFTR and was the second agent to gain approval as therapy of CF, but was approved for use only in combination with ivacaftor, and specifically for patients who are homozygous for the Phe508del (F508del) mutation in the CFTR. Phen508del is the most frequent mutation in CFTR found in patients with CF and is associated with a lack of trafficking of the transporter to the cell surface. In vitro, lumacaftor was found to partially correct this trafficking error. Lumacaftor combined with ivacaftor was approved for use in patients homozygous for Phe508del CFTR in 2015 and is available as tablets consisting of 200 mg of lumacaftor and 125 mg of ivacaftor under the brand name Orkambi. Side effects of these agents are generally mild, but can include headache, nasal congestion, abdominal pain, diarrhea, nausea, dizziness and rash.

Tezacaftor (tez" a kaf' tor) is a "corrector" of the CFTR and was the third agent to gain approval, but only in combination with ivacaftor, and specifically for patients who are homozygous for the Phe508Del (F508del) mutation in the CFTR or are heterozygous and have another mutation in CFTR found in patients with CF and is associated with a lack of trafficking of the transporter to the cell surface. In vitro, tezacaftor was found to partially correct this trafficking error. Tezacaftor combined with ivacaftor was approved for use in the United States as therapy for patients with cystic fibrosis in 2018 and is available as tablets of fixed dose of 100 mg tezacaftor with 150 mg of ivacaftor co-packaged with tablets of 150 mg of ivacaftor alone under the brand name Symdeko. Side effects of these agents are generally mild but can include headache, nasal congestion, abdominal pain, diarrhea, nausea, dizziness and rash.

Elexacaftor (el ex” a kaf’ tor) is also a “corrector” of the CFTR and was the fourth agent to gain approval, but only in combination with tezacaftor and ivacaftor (E/T/I: triple therapy). Initially evaluated in patients who were homozygous for the Phe508del allele, further trials showed that it was effective in patients with only one Phe508 allele and a variety of second mutated alleles. Clinical trials of this triple combination therapy was found to rapidly improve pulmonary function tests and clinical symptoms resulting in a decrease in acute exacerbations and sweat chloride concentrations, weight gain and improved pulmonary function and quality of life. Triple therapy with elexacaftor, tezacaftor and ivacaftor was approved for use in patients with cystic fibrosis aged 12 years or older with at least one Phen508del allele in the United States in 2019 under the brand name Trikafta. The recommended dosage is two tablets of a fixed combination of 100 mg of elexacaftor, 50 mg of tezacaftor, and 75 mg of ivacaftor each morning and a second tablet of ivacaftor 150 mg alone each evening. Because approximately 85% of patients with cystic fibrosis have at least one Phe508del allele, triple therapy is applicable to most patients and has replaced previous combinations of “caftors” as the standard of therapy.

Vanzacaftor (van” za kaf’ tor) is a “corrector” of the CFTR improving cellular processing and trafficking of mutated CF transmembrane conductance regulator. It was the fifth agent to gain approval but only in combination with tezacaftor and deutivacaftor [a deuterated form of ivacaftor] under the brand name Alyftrek. This form of triple therapy [V/T/D] was approved in 2025 to treat patients, six years of age or above, with responsive CFTR mutations such as F508del. In clinical trials, Alyftrek was shown to be non-inferior to Trikafta [E/T/I] in improving pulmonary function after 24 and 52 weeks and was more effective in reducing sweat chloride concentrations. Alyftrek is available as tablets of either 4/20/50 mg or 10/20/125 mg of vanzacaftor/tezacaftor/deutivacaftor each. For children 6 to 11 years of age, the recommended dose is 3 tablets of the lower dose version once daily. For adults and for children 12 years of age of older, the recommended dose is 2 tablets of the higher dose version once daily.

Deutivacaftor (doo tiv’ a caf’ tor), the sixth agent to gain approval as therapy of cystic fibrosis, is a deuterated form of ivacaftor that allows for its better absorption and duration of action of the active ingredient, allowing for once a day dosing. It has not been evaluated as monotherapy and is available only in fixed combination with vanzacaftor and tezacaftor (V/T/D) as Alyftrek.

Common side effects of CFTR modulator therapies include an initial worsening of cough, rhinorrhea, sinusitis, nasal congestion and dyspnea, elevations in ALT, bilirubin and CPK levels, abdominal pain, diarrhea, and rash. Less common but potentially severe complications include cataracts, hepatitis, pancreatitis and acute cholecystitis.

### Hepatotoxicity

In large randomized controlled trials of ivacaftor with or without lumacaftor or tezacaftor, up to 25% of subjects had some degree of serum aminotransferase elevations during therapy. The elevations, however, were generally transient and mild and were above 3 times the upper limit of normal (ULN) in only 2% to 5% of patients. The abnormalities were usually asymptomatic and often resolved spontaneously without dose adjustment. Furthermore, in several studies, similar rates of serum enzyme elevations were noted in the placebo treated groups. Nevertheless, serum aminotransferase elevations resulted in dose modification or interruption in 1% to 2% of patients on ivacaftor alone or with lumacaftor or tezacaftor.

In prelicensure clinical trials of the triple therapy of elexacaftor, tezacaftor and ivacaftor, higher rates of serum enzyme elevations were reported which in some cases were accompanied by elevations in serum bilirubin. Most abnormalities resolved spontaneously and enzymes rapidly improved upon discontinuation. Since approval of triple therapy, several case reports of clinically apparent liver injury were reported to the FDA, generally arising after weeks or months of treatment and resolving with discontinuation. Most cases have been mildly symptomatic with no or only transient and mild jaundice but several were more severe with liver failure leading to death or liver transplantation. As a consequence, triple therapy CFTR modulators now have boxed warnings about hepatotoxicity, liver failure, death and liver transplantation. There have been no reports of chronic hepatitis or vanishing bile duct syndrome linked to triple therapy. Patients with cystic fibrosis can, not infrequently, have underlying liver disease with chronic, intermittent serum aminotransferase and alkaline phosphatase elevations, occasionally associated with progressive fibrosis or nodular regenerative hyperplasia and non-cirrhotic portal hypertension.

In addition, case series of acute cholecystitis developing within days or weeks of starting triple therapy have been reported, and are probably due to the increased biliary fluid secretion and clearance of biliary sludge and stones with the sudden increased bile flow. Gallstones are frequent in patients with cystic fibrosis and often result in cholecystectomy.

Combination of elexacaftor, tezacaftor, and ivacaftor [E/T/I] or vanzacaftor, tezacaftor, and deutivacaftor [V/T/D] likelihood score: B (likely cause of clinically apparent liver injury usually without jaundice but with rare instances of acute liver failure).

### Mechanism of Injury

The mechanism by which the CFTR correctors might cause liver injury is not known. They are extensively metabolized in the liver by the cytochrome P450 system (largely CYP 3A) and liver injury might be caused by a toxic or immunogenic product of their metabolism. Triple therapy is susceptible to drug-drug interactions, particularly with strong inducers (such as rifampin and St. John's wort), which may result in suboptimal drug levels or strong inhibitors of CYP 3A4 (such as ketoconazole) that might result in higher than normal drug levels and increased toxicity.

### Outcome and Management

While chronic therapy with CFTR correctors can be associated with mild-to-moderate serum aminotransferase elevations, they have been only rarely linked to cases of clinically apparent liver injury with jaundice. Monitoring of routine liver tests (ALT, AST, alkaline phosphatase, and bilirubin) is recommended for patients starting triple therapy with repeat testing while on therapy every month for 6 months, every 3 months for the next 12 months and then at least annually. Patients who develop aminotransferase elevations on therapy should be monitored more frequently, and dosing should be interrupted if symptoms or jaundice appear or if aminotransferase levels rise above 5 times ULN, with caution in restarting once they fall into the normal range. The safety and efficacy of these recommendations in patients with CF who have underlying liver disease has not been demonstrated, and increased monitoring and caution is appropriate in patients with preexisting liver abnormalities. Triple therapy should not be used in patients with decompensated cirrhosis (Child-Pugh C).

Drug Class: Genetic Disorder Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ivacaftor – Kalydeco®

Lumacaftor/Ivacaftor – Orkambi®

Tezacaftor/Ivacaftor – Symdeko®

Elexacaftor/Tezacaftor/ Ivacaftor – Trikafta®

Vanzacaftor/Tezacaftor/Deutivacaftor – Alyftrek®

DRUG CLASS

Cystic Fibrosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ivacaftor)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Ivacaftor | 873054-44-5 | C24-H28-N2-O3
Lumacaftor | 936727-05-8 | C24-H18-F2-N2-O5
Tezacaftor | 1152311-62-0 | C26-H27-F3-N2-O6
Elexacaftor | 2216712-66-0 | C26-H34-F3-N7-O4-S
Deutivacaftor | 1413431-07-8 | C24-H28-N2-O3 | CID: 71470491
Vanzacaftor | 2374124-49-7 | C32-H39-N7-O4-S | CID: 139399801

## ANNOTATED BIBLIOGRAPHY

References updated: 28 August 2025

Abbreviations used: CF, cystic fibrosis; CFTR, cystic fibrosis transmembrane conductance regulator; ULN, upper limit of the normal range; E/T/I, elexacaftor/tezacaftor/ivacaftor [Trikafta]; V/T/D, vanzacaftor/tezacaftor/ deutivacaftor [Alyftrek].

https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/212273Orig1s000MultidisciplineR.pdf (FDA integrated review of the sponsor’s application for approval of Trikafta [E/T/I] as therapy of cystic fibrosis mentions that ALT elevations arose in 10% of patients on E/T/I vs 4% on placebo and bilirubin elevations in 5% vs 1%, but there were no instances of ALT concurrent with bilirubin elevations attributable to therapy and no discontinuations because of ALT elevations).
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2025/218730Orig1s000IntegratedR.pdf (FDA integrated review of the sponsors application for approval of Alyftrek [V/T/D] as therapy of cystic fibrosis mentions that V/T/D “is safe for its intended use” and its safety was similar to that of E/T/I, ALT or AST elevations above 3 times ULN occurred in 6% of 480 patients receiving V/T/I vs 3% of 491 on E/T/I, and discontinuations for enzyme elevations occurred in 1.5% vs 0.6%, but there were no instances of drug-induced liver injury with jaundice).
Ramsey BW, Davies J, McElvaney NG, Tullis E, Bell SC, Drevínek P, Griese M, et al.; VX08-770-102 Study Group. A CFTR potentiator in patients with cystic fibrosis and the G551D mutation. N Engl J Med 2011; 365: 1663-72. (Among 161 patients with CF and the Gly551Asp mutation of CFTR, pulmonary function improved more and respiratory exacerbations were less in those who were treated with ivacaftor compared to placebo; serum ALT levels above 2 times ULN occurred in 9.6% of ivacaftor vs 11.6% of placebo recipients, and were above 5 times ULN in 3.6% vs 1.3%). 22047557
Davis PB. Therapy for cystic fibrosis--the end of the beginning? N Engl J Med 2011; 365: 1734-5. (Editorial in response to Ramsey [2011]). 22047565
Hebestreit H, Sauer-Heilborn A, Fischer R, Käng M, Mainz JG. Effects of ivacaftor on severely ill patients with cystic fibrosis carrying a G551D mutation. J Cyst Fibros 2013; 12: 599-603. (Among 14 patients with severe lung disease due to CF who were treated with ivacaftor for up to 1 year, 1 developed ALT elevations of 3 to 4 times ULN, 1 had AST elevations and 1 bilirubin elevations, but all resolved spontaneously without drug discontinuation). 23757359
Davies JC, Wainwright CE, Canny GJ, Chilvers MA, Howenstine MS, Munck A, Mainz JG, et al.; VX08-770-103 (ENVISION) Study Group. Efficacy and safety of ivacaftor in patients aged 6 to 11 years with cystic fibrosis with a G551D mutation. Am J Respir Crit Care Med 2013; 187: 1219-25. (Among 52 children with CF and CFTR mutation Gly551Asp treated with ivacaftor or placebo for 48 weeks, FEV1 improved significantly in ivacaftor, but not placebo recipients [12.6% vs 0.1%], while adverse event rates were similar and there were "no clinically important trends attributable to ivacaftor" in liver test results). 23590265
Wood ME, Smith DJ, Reid DW, Masel PJ, France MW, Bell SC. Ivacaftor in severe cystic fibrosis lung disease and a G551D mutation. Respirol Case Rep 2013; 1: 52-4. (Among 3 adults with CF, CFTR Gly551Asp mutations and severe lung disease who were treated with ivacaftor for 24 weeks, one developed "elevated liver enzymes" which required drug withdrawal, but later tolerated restarting ivacaftor without recurrence of liver injury). 25473543
Holmes D. False dawn for cystic fibrosis disease modifiers? Nat Rev Drug Discov 2014; 13: 713-4. (Editorial on the results of trials of ivacaftor/lumacaftor combination therapy focusing on the modest effects achieved [2.6-4% increase in FEV1] and recent in vitro data suggesting that ivacaftor may reverse the effects of lumacaftor on the Phe508del mutant CFTR). 25270946
McKone EF, Borowitz D, Drevinek P, Griese M, Konstan MW, Wainwright C, Ratjen F, et al.; VX08-770-105 (PERSIST) Study Group. Long-term safety and efficacy of ivacaftor in patients with cystic fibrosis who have the Gly551Asp-CFTR mutation: a phase 3, open-label extension study (PERSIST). Lancet Respir Med 2014; 2: 902-10. (Among 192 adults and children with CF and Gly551Asp mutant CFTR who were treated in an extension study after the 48 week-controlled trials of ivacaftor [Ramsey 2011, Davies 2013], efficacy was maintained and there were no new safety concerns, although 9 patients [5%] developed ALT elevations above 5 times ULN [without bilirubin elevations] and required dose interruptions). 25311995
Boyle MP, Bell SC, Konstan MW, McColley SA, Rowe SM, Rietschel E, Huang X, et al.; VX09-809-102 study group. A CFTR corrector (lumacaftor) and a CFTR potentiator (ivacaftor) for treatment of patients with cystic fibrosis who have a phe508del CFTR mutation: a phase 2 randomised controlled trial. Lancet Respir Med 2014; 2: 527-38. (In a dose finding study of lumacaftor alone and in combination with ivacaftor vs placebo in 188 patients with CF and the Phe508del mutant CFTR, there was little change in lung function [FEV1] and one patient developed ALT elevations, but before starting active therapy). 24973281
Hayes D Jr, Warren PS, McCoy KS, Sheikh SI. Improvement of hepatic steatosis in cystic fibrosis with ivacaftor therapy. J Pediatr Gastroenterol Nutr 2015; 60: 578-9. (17 year old girl with Gly551Asp mutant CFTR and hepatic steatosis was treated with ivacaftor for 2 years and was found to have resolution of the steatosis by MR imaging, but had also received ursodiol which was associated temporarily with improvements in serum enzyme elevations). 25688481
Taylor-Cousar J, Niknian M, Gilmartin G, Pilewski JM; for the VX11-770-901 investigators. Effect of ivacaftor in patients with advanced cystic fibrosis and a G551D-CFTR mutation: Safety and efficacy in an expanded access program in the United States. J Cyst Fibros 2016; 15 (1): 116-22. (Among 44 adults and children with CF [Gly551Asp mutant CFTR] and severe lung disease who were treated with ivacaftor for 24 weeks, FEV1 improved by an average of 5.5% and most patients gained weight; liver test abnormalities were noted in 1 patient [2%], but no details were provided). 25682022
Wainwright CE, Elborn JS, Ramsey BW, Marigowda G, Huang X, Cipolli M, Colombo C, et al.; TRAFFIC and TRANSPORT Study Groups. Lumacaftor-ivacaftor in patients with cystic fibrosis homozygous for Phe508del CFTR. N Engl J Med 2015; 373: 220-31. (Among 1108 adult and adolescent patients with CF who were homozygous for the Phe508del CFTR mutant allele and were treated with the combination of lumacaftor and ivacaftor for 24 weeks, ALT elevations above 3 times ULN occurred in 5.2% of patients on the drug combination vs 5.1% on placebo; drug discontinuations for liver test elevations occurred in 7 patients on the drug combination vs none on placebo, and concurrent ALT and bilirubin elevations occurred only in drug-treated patients [n=3]). 25981758
Jones AM, Barry PJ. Lumacaftor/ivacaftor for patients homozygous for Phe508del-CFTR: should we curb our enthusiasm? Thorax 2015; 70: 615-6. (Commentary on the safety and efficacy of the combination of lumacaftor with ivacaftor in patients with CF [with the Phe508del mutation in the CFTR] mentions the rather modest improvements in lung function found in the controlled trials of the combination [Wainwright 2015], and the finding of significant elevations in both ALT and bilirubin levels in 3 treated patients raising the issue of interaction between the two agents). 26071414
Moss RB, Flume PA, Elborn JS, Cooke J, Rowe SM, McColley SA, Rubenstein RC, et al.; VX11-770-110 (KONDUCT) Study Group. Efficacy and safety of ivacaftor in patients with cystic fibrosis who have an Arg117His-CFTR mutation: a double-blind, randomised controlled trial. Lancet Respir Med 2015; 3: 524-33. (Among 69 adults and children with CF and the Arg117His mutant CFTR treated with ivacaftor or placebo for 24 weeks, sweat chloride levels decreased with treatment, but FEV1 results did not improve significantly; no mention of ALT elevations or clinically apparent liver injury). 26070913
Elborn JS, Ramsey BW, Boyle MP, Konstan MW, Huang X, Marigowda G, Waltz D, et al.; VX-809 TRAFFIC and TRANSPORT study groups. Efficacy and safety of lumacaftor/ivacaftor combination therapy in patients with cystic fibrosis homozygous for Phe508del CFTR by pulmonary function subgroup: a pooled analysis. Lancet Respir Med 2016; 4: 617-26. (Pooled analysis of two placebo controlled trials of lumacaftor/ivacaftor in 1108 patients with CF [and Phe508del CFTR mutation], focuses on improvements in pulmonary function test results; no mention of ALT elevations, hepatotoxicity or non-pulmonary serious adverse events). 27298017
Hubert D, Dehillotte C, Munck A, David V, Baek J, Mely L, Dominique S, et al. Retrospective observational study of French patients with cystic fibrosis and a Gly551Asp-CFTR mutation after 1 and 2 years of treatment with ivacaftor in a real-world setting. J Cyst Fibros 2018; 17(1): 89-95. (Among 57 patients with CF [and Gly551Asp-CFTR mutation] treated with ivacaftor for 1-2 years, "no significant adverse events were reported", although therapy was discontinued in 2 patients because of abnormal liver enzyme levels or cirrhosis). 28711222
Ratjen F, Hug C, Marigowda G, Tian S, Huang X, Stanojevic S, Milla CE, et al; VX14-809-109 investigator group. Efficacy and safety of lumacaftor and ivacaftor in patients aged 6-11 years with cystic fibrosis homozygous for F508del-CFTR: a randomised, placebo-controlled phase 3 trial. Lancet Respir Med 2017; 5: 557-67. (Among 204 children with CF [homozygous for Phen508del CFTR mutation] treated with lumacaftor/ ivacaftor or placebo, pulmonary function tests improved more frequently in drug treated children, while overall adverse event rates were similar; ALT or AST elevations above 3 times ULN occurred in 13% vs 8%, and above 5 times in 5% vs 3%, although all liver enzyme elevations were self-limited and not accompanied by jaundice or symptoms). 28606620
Konstan MW, McKone EF, Moss RB, Marigowda G, Tian S, Waltz D, Huang X, et al. Assessment of safety and efficacy of long-term treatment with combination lumacaftor and ivacaftor therapy in patients with cystic fibrosis homozygous for the F508del-CFTR mutation (PROGRESS): a phase 3, extension study. Lancet Respir Med 2017; 5: 107-18. (Among 340 patients with CF [Phen508del CFTR mutation] who continued lumacaftor/ivacaftor therapy after participation in randomized controlled trials [Wainwright 2015; Elborn 2016], the beneficial effects of therapy appeared to be maintained while ALT or AST elevations above 3 times ULN arose in 8% of patients, but all elevations were self-limited and none were accompanied by bilirubin elevations; one subject developed acute hepatitis E). 28011037
Rowe SM, McColley SA, Rietschel E, Li X, Bell SC, Konstan MW, Marigowda G, Waltz D, Boyle MP; VX09-809-102 Study Group. Lumacaftor/ivacaftor treatment of patients with cystic fibrosis heterozygous for F508del-CFTR. Ann Am Thorac Soc 2017; 14: 213-9. (Among 126 patients with CF [heterozygous for phe508del CFTR mutation] treated with lumacaftor/ivacaftor for 56 days, overall side effect rates were similar in the two groups; one drug treated subject discontinued therapy because of ALT and AST elevations). 27898234
Milla CE, Ratjen F, Marigowda G, Liu F, Waltz D, Rosenfeld M; VX13-809-011 Part B Investigator Group *. Lumacaftor/ivacaftor in patients aged 6-11 years with cystic fibrosis and homozygous for F508del-CFTR. Am J Respir Crit Care Med 2017; 195: 912-20. (Among 56 children with CF [homozygous for phe508del] treated with lumacaftor/ivacaftor for 24 weeks, ALT or AST elevations above 5 times ULN occurred in 5 patients [9%], and 3 stopped therapy because of enzyme elevations, but none developed jaundice or symptoms). 27805836
Rowe SM, Daines C, Ringshausen FC, Kerem E, Wilson J, Tullis E, Nair N, et al. Tezacaftor-Ivacaftor in residual-function heterozygotes with cystic fibrosis. N Engl J Med 2017; 377: 2024-35. (Among 248 patients with cystic fibrosis heterozygous for the Phe508del mutation in CFTR treated in a cross over study of tezacaftor/ivacaftor vs ivacaftor alone vs placebo, improvements in lung function were greater with active treatment, but adverse event rates were similar in all 3 groups, ALT elevations above 3 times ULN occurring in 11.7% of tezacaftor/ivacaftor, 13.4% on ivacaftor alone and 8% on placebo, but none were accompanied by jaundice or led to early discontinuation). 29099333
Taylor-Cousar JL, Munck A, McKone EF, van der Ent CK, Moeller A, Simard C, Wang LT, et al. Tezacaftor-ivacaftor in patients with cystic fibrosis homozygous for phe508del. N Engl J Med 2017; 377: 2013-23. (Among 509 patients with cystic fibrosis who were homozygous for phe508del who were treated with tezacaftor/ivacaftor or placebo for 24 weeks improvement in lung function was treated with the active drug than with placebo, while adverse event rates were similar, ALT elevations above 3 times ULN occurring in 4.7% vs 3.2% and leading to early discontinuation in 0.4% vs 0.2% of subjects). 29099344
Tezacaftor/Ivacaftor (Symdeko) for cystic fibrosis. Med Lett Drugs Ther 2018; 60 (1558): 174-6. (Concise summary of the mechanism of action, clinical efficacy, safety and costs of tezacaftor/ivacaftor; mentions that serum aminotransferase levels can occur and that monitoring of liver tests should be done before starting therapy followed by every 3 months for the first year and annually thereafter). 30335045
Davies JC, Moskowitz SM, Brown C, Horsley A, Mall MA, McKone EF, Plant BJ, et al.; VX16-659-101 Study Group. VX-659-tezacaftor-ivacaftor in patients with cystic fibrosis and one or two Phe508del alleles. N Engl J Med 2018; 379: 1599-611. (Among 117 selected patients with cystic fibrosis treated with tezacaftor/ivacaftor with or without VX-659 or placebo, improvements in lung function and sweat chloride were greatest with triple therapy, but that 3 of 49 patients receiving triple therapy developed ALT elevations above 3 times ULN, but the abnormalities resolved even without dose reduction). 30334693
Keating D, Marigowda G, Burr L, Daines C, Mall MA, McKone EF, Ramsey BW, et al.; VX16-445-001 Study Group.VX-445-tezacaftor-ivacaftor in patients with cystic fibrosis and one or two Phe508del alleles. N Engl J Med 2018; 379: 1612-20. (Among 123 selected patients with cystic fibrosis treated with tezacaftor/ivacaftor with or without VX445 or placebo, improvements in lung function and sweat chloride were greatest with triple therapy and adverse event rates were similar in all groups, ALT or AST elevations occurring in 28% receiving VX445, 28% receiving tezacaftor/ivacaftor and 33% on placebo and were above 5 times ULN in only 1 subject). 30334692
Middleton PG, Mall MA, Dřevínek P, Lands LC, McKone EF, Polineni D, Ramsey BW, et al.; VX17-445-102 Study Group. Elexacaftor-tezacaftor-ivacaftor for cystic fibrosis with a single Phe508del allele. N Engl J Med 2019;381:1809-1819. (Among 402 patients with cystic fibrosis [age 12 years or older] with one Phe508del allele and one minimal function allele treated with triple therapy [elexacaftor, tezacaftor, ivacaftor] vs placebo for 24 weeks, pulmonary function tests and symptoms improved and acute exacerbations and sweat chloride concentrations decreased while adverse events were generally mild and only slightly greater than placebo, ALT elevations arising in 11% vs 4% and being above 3 times ULN in 8% vs 5.5%, 5 times ULN in 2.5% vs 1.5% and 8 times ULN in 1.5% vs 1% with no early discontinuations because of liver test abnormalities and no accompanying jaundice). 31697873
Heijerman HGM, McKone EF, Downey DG, Van Braeckel E, Rowe SM, Tullis E, Mall MA, et al.; VX17-445-103 Trial Group. Efficacy and safety of the elexacaftor plus tezacaftor plus ivacaftor combination regimen in people with cystic fibrosis homozygous for the F508del mutation: a double-blind, randomised, phase 3 trial. Lancet. 2019;394(10212):1940-1948. (Among 107 patients with cystic fibrosis and homozygous for the F508del mutation were treated with tezacaftor and ivacaftor with or without elexacaftor for 4 weeks, pulmonary function tests and sweat chloride improved with addition of elexacaftor and adverse event rates were similar, although ALT elevations above 3 times ULN occurred in 4 elexacaftor treated [7%] versus none given placebo; there were no severe hepatic adverse events or cases of clinically apparent liver injury). 31679946
Hoy SM. Elexacaftor/Ivacaftor/Tezacaftor: first approval. Drugs. 2019;79:2001-2007. (Review of the mechanism of action, history of development, clinical efficacy and safety of triple therapy using ivacaftor, tezacaftor, and elexacaftor [E/T/I] shortly after the approval of this regimen as therapy of cystic fibrosis in the US, mentions that ALT elevations occurred in a small proportion of treated patients at a higher rate than with placebo). 31784874
Elexacaftor/tezacaftor/ivacaftor (Trikafta) for cystic fibrosis. Med Lett Drugs Ther. 2020;62(1589):5-7. (Concise review of the mechanisms of action, clinical efficacy, safety and costs of E/T/I for CF shortly after its approval in the US mentions that adverse events leading to discontinuation occurred in 1% of patients and aminotransferase elevations above twice the upper limit of normal arose in 11% [vs 4% with placebo] and bilirubin elevations in 4% [vs <1%]). 31999662
Safirstein J, Grant JJ, Clausen E, Savant D, Dezube R, Hong G. Biliary disease and cholecystectomy after initiation of elexacaftor/ivacaftor/tezacaftor in adults with cystic fibrosis. J Cyst Fibros. 2021;20:506-510. (Case series of 7 patients with CF who developed biliary colic within 1-27 days after starting the combination of E/T/I, 6 of whom underwent cholecystectomy and most were then able to tolerate triple therapy without further biliary pain). 32736949
Brennan S, Marmor I, Schafer C, Ko J, Torres Garcia JA, Rosman IS, Coughlin C, et al. Serum sickness-like reaction following initiation of elexacaftor/tezacaftor/ivacaftor therapy. Pediatr Pulmonol. 2020;55:2846-2847. (12 year old boy with cystic fibrosis developed nausea, abdominal pain, fever, pruritus and rash starting 5 days after initiation of E/T/I triple therapy with fever, joint swelling and leukocytosis without eosinophilia, creatinine or ALT elevations, responding to a 3 week course of prednisone). 32956574
Hu MK, Wood G, Dempsey O. 'Triple therapy' (elexacaftor, tezacaftor, ivacaftor) skin rash in patients with cystic fibrosis. Postgrad Med J. 2020 Dec 11: postgradmedj-2020-139264. Epub ahead of print. (24 year old woman with cystic fibrosis developed generalized rash 8 days after starting triple therapy with E/T/I, which resolved rapidly with discontinuation and corticosteroid therapy and did not recur when she was restarted with a slow initial titration).
Griese M, Costa S, Linnemann RW, Mall MA, McKone EF, Polineni D, Quon BS, et al. Safety and efficacy of elexacaftor/tezacaftor/ivacaftor for 24 weeks or longer in people with cystic fibrosis and one or more F508del alleles: interim results of an open-label phase 3 clinical trial. Am J Respir Crit Care Med. 2021;203:381-385. (Among 506 patients with cystic fibrosis enrolled in an ongoing open-label extension study of triple therapy [E/T/I], frequent adverse reactions included paradoxical exacerbation of pulmonary disease, cough and sore throat and rash in 5%, early discontinuations in 7 patients 4 for ALT elevations and 1 for rash, while ALT elevations occurred in 36 [7%] of patients, that were above 3 times ULN in 6%, 5 times ULN in 2%, and 8 times ULN in 0.6%). 32969708
Stylemans D, François S, Vincken S, Verbanck S, Vanderhelst E. A case of self-limited drug induced liver injury under treatment with elexacaftor/tezacaftor/ivacaftor: When it is worth taking the risk. J Cyst Fibros. 2021;20:712-714. (58 year old woman with severe cystic fibrosis developed enzyme elevations 1-2 weeks after starting E/T/I that rose to ALT of 15 times ULN and Alk P of 5 times ULN but normal bilirubin; stopping therapy resulted in improvement and restarting in worsening, but eventually with initial low dose treatment, full dose therapy was tolerated with normal liver tests). 34134936
Zemanick ET, Taylor-Cousar JL, Davies J, Gibson RL, Mall MA, McKone EF, McNally P, et al. A phase 3 open-label study of elexacaftor/tezacaftor/ivacaftor in children 6 through 11 years of age with cystic fibrosis and at least one F508del allele. Am J Respir Crit Care Med. 2021;203:1522-1532. (Among 66 children [ages 6 to 11] with cystic fibrosis and at least one F508del allele treated with E/T/I for 24 weeks, pulmonary function and clinical symptoms improved and adverse events, while common [98%], were usually transient and mild-to-moderate in severity; ALT or AST elevations above times ULN arose in 7 children but only one was above 5 times ULN and none required dose interruption; rash occurred in 24% but resolved without stopping therapy in all but one). 33734030
Lowry S, Mogayzel PJ, Oshima K, Karnsakul W. Drug-induced liver injury from elexacaftor/ivacaftor/ tezacaftor. J Cyst Fibros. 2021:S1569-1993(21)01297-2. Epub ahead of print. (21 year old woman with cystic fibrosis was found to have abnormal liver tests 5 months after starting E/T/I, which worsened despite stopping treatment with peak ALT 2707 U/L and bilirubin 3.1 mg/dL one month later, biopsy showing moderate inflammation and centrolobular necrosis but with eventual resolution and normal liver tests 6 months later).
Barry PJ, Mall MA, Álvarez A, Colombo C, de Winter-de Groot KM, Fajac I, McBennett KA, et al.; VX18-445-104 Study Group. Triple therapy for cystic fibrosis Phe508del-gating and -residual function genotypes. N Engl J Med. 2021;385:815-825. (Among 132 patients [ages 12 years or more] with cystic fibrosis and one Phe508del allele and a second allele with either a gating- or a residual function genotype treated with triple therapy [E/T/I] or an active control therapy [ivacaftor alone or with tezacaftor], pulmonary function and symptoms improved more with E/T/I while adverse events were generally similar, ALT elevations arising in 6% vs none and resulting in early discontinuation in 1 patient; rash arose in 3% vs 4%). 34437784
Salehi M, Iqbal M, Dube A, AlJoudeh A, Edenborough F. Delayed hepatic necrosis in a cystic fibrosis patient taking Elexacaftor/Tezacaftor/Ivacaftor (Kaftrio). Respir Med Case Rep. 2021;34:101553.. (45 year old man with CF started Trikafta [E/T/I] and had marked improvement in pulmonary function, but after 7 months serum ALT and AST levels began to rise and continued despite dose modification and brief interruption, ultimately leading to discontinuation but liver enzyme elevations continued without symptoms or jaundice for another 2 months, eventually falling into the normal range while pulmonary function worsened). 34815934
Wood M, Babowicz F, Kennedy AG, Antell M, Gilhooly E, Tompkins BJ, Reddy SS. Incidence of transaminitis in adults with cystic fibrosis taking elexacaftor/tezacaftor/ivacaftor. J Am Pharm Assoc (2003). 2023;63:920-924.. (Among 83 patients with CF started on E/T/I, serum ALT or AST elevations arose in 62 [75%] but to above 3 times ULN in only 9 [11%] that mostly resolved spontaneously, peak ALT 1125 U/L, bilirubin 2.0 mg/dL, requiring dose adjustment in 2 and temporary stopping in 2, none with symptoms and none requiring permanent discontinuation). 36872183
Tewkesbury D, Jones AM, Bright-Thomas R, Cratchley A, Hanley KP, Wyatt J, Athwal V, et al. Aetiology of significant liver test abnormalities in a single-centre cohort of people with cystic fibrosis exposed to elexacaftor/tezacaftor/ivacaftor, utilizing the updated RUCAM. Drugs. 2023;83:1699-1707.. (Among 337 patients with CF treated with E/T/I, 19 [6%] developed serum ALT or AST elevations above 3 times ULN, but another cause was found in 12 [viral illness, alcohol, another drug cause, pre-existing CF liver disease, exercise, trauma] and in the remainder the injury was usually self-limited and mild, only one patient required permanent discontinuation after appearance of hepatic synthetic dysfunction). 37966582
Kinuani R, Ezri J, Kernen Y, Rochat I, Blanchon S. Case report: when cystic fibrosis, elexacaftor/tezacaftor/ivacaftor therapy, and alpha1 antitrypsin deficiency get together. Front Pediatr. 2024;12:1378744.. (10 year old boy with CF developed mild elevations of serum ALT and AST [2 to 3 times ULN] after starting lumacaftor and ivacaftor [L/I] but values increased markedly after switching to E/T/I [ALT~440 U/L, AST ~190 U/L] with nausea and fatigue but no jaundice, and which resolved slowly on stopping, while he later tolerated L/I with continued mild enzyme elevations). 38655277
Shi A, Nguyen H, Kuo CB, Beringer PM. Drug-induced liver injury associated with elexacaftor/tezacaftor/ivacaftor: a pharmacovigilance analysis of the FDA adverse event reporting system (FAERS). J Cyst Fibros. 2024;23:566-572.. (Analysis of the FDA Adverse Event Reporting System from 2019 to 2022 identified 452 reports of liver injury attributed to E/T/I with a mean time to onset of 50 days, 27% hospitalized, and 1.5% considered life-threatening). 38233246
Kolaczkowski TJ, Bevan A, Legg J, Self J, Allenby M. Elevated liver function tests in infants exposed to elexacaftor-tezacaftor-ivacaftor in utero and while breastfeeding - case reports. J Cyst Fibros. 2025;24:16-18.. (Two newborns of mothers with CF, who took E/T/I throughout pregnancy and afterwards while breast feeding, were monitored and found to have mild ALT [peak 124 U/L] and AST [peak 49 and 94 U/L] elevations at 3 to 9 months [one with transient mild increase in bilirubin] without symptoms; screening for cataracts was negative in both). 39424519
Johnson E, Riddles T, Smith D, Henderson D, Masel P, Reid DW, Moore V, et al. Disproportionate rates of liver injury in people with cystic fibrosis on elexacaftor/tezacaftor/ivacaftor in Queensland, Australia. Gastro Hep Adv. 2025;4:100641.. (Among 281 Australians with CF treated with E/T/I between 2019 and 2024, 56 [20%] had significant adverse reactions, 23 [8%] of whom had hepatotoxicity which required permanent cessation in 3 and required dose adjustment in 16, yet E/T/I was often tolerated after slow reinitiation, half dosage, or coadministration with ursodiol). 40692822
Terlizzi V, Fevola C, Cecchetti M, Terminiello A, Curci F, Bartolini E, Rubino C, et al. Effect of elexacaftor-tezacaftor-ivacaftor on liver transient elastography, fibrosis indices and blood tests in children with cystic fibrosis. J Cyst Fibros. 2025;24:574-580.. (Among 27 children with CF monitored after introduction of E/T/I, pre-existing abnormalities in liver test results improved within 3 months of starting therapy including liver stiffness which was elevated in 5 children before therapy improved in all becoming normal in 4 by 3 months). 39800644
Urbantat RM, Behan L, Wisniewski S, Gardner J, Stahl M, Mall MA, Peckham D, et al. Immunogenic adverse events to CFTR modulators – an international survey. J Cyst Fibros. 2025;24:521-525.. (An international survey of 89 CF centers with more than 12,000 patients, identified 200 patients who discontinued therapy because of an immunogenic adverse reactions which were hepatic in 34% and rash in 49%). 40107912
Uluer AZ, MacGregor G, Azevedo P, Indihar V, Keating C, Mall MA, McKone EF, et al.; VX18-121-101; VX18-561-101 Study Groups. Safety and efficacy of vanzacaftor-tezacaftor-deutivacaftor in adults with cystic fibrosis: randomised, double-blind, controlled, phase 2 trials. Lancet Respir Med. 2023;11:550-562.. (Among 86 adults with cystic fibrosis and at least one F508del allele enrolled in two phase 2 trials of vanzacaftor-tezacaftor-deutivacaftor [V/T/D], ALT or AST elevations 3 to 5 times ULN arose in 3 patients [6%], but none developed symptoms or jaundice and there were no serious hepatic adverse events or discontinuations for enzyme elevations). 36842446
Keating C, Yonker LM, Vermeulen F, Prais D, Linnemann RW, Trimble A, Kotsimbos T, et al.; VX20-121-102 Study Group; VX20-121-103 Study Group. Vanzacaftor-tezacaftor-deutivacaftor versus elexacaftor-tezacaftor-ivacaftor in individuals with cystic fibrosis aged 12 years and older (SKYLINE Trials VX20-121-102 and VX20-121-103): results from two randomised, active-controlled, phase 3 trials. Lancet Respir Med. 2025;13:256-271.. (Among 398 patients, ages 12 years and over, with cystic fibrosis and responsive CFTR mutations treated with V/T/D vs E/T/I, pulmonary improvement was similar in the two groups and pooled safety data suggested that both were “generally safe and well tolerated” with ALT or AST elevations in 9% vs 7% which were above 5 times ULN in 2.5% vs 1.2%, with no confirmed case of drug-related liver injury with jaundice). 39756424
Hoppe JE, Kasi AS, Pittman JE, Jensen R, Thia LP, Robinson P, Tirakitsoontorn P, et al.; VX21-121-105 Study Group. Vanzacaftor-tezacaftor-deutivacaftor for children aged 6-11 years with cystic fibrosis (RIDGELINE Trial VX21-121-105): an analysis from a single-arm, phase 3 trial. Lancet Respir Med. 2025;13:244-255.. (Among 78 children, ages 6 to 11 years, with CF treated with V/T/D for 24 weeks, 75 [95%] had at least one adverse event, 6 [8%] were serious, and 4 patients had ALT elevations above 3 times ULN none of which were associated with jaundice or required drug discontinuation). 39756425
Vanzacaftor, tezacaftor, and deutivacaftor (Alyftrek) for cystic fibrosis. Med Lett Drugs Ther. 2025;67(1724):41-43.. (Concise summary of the mechanism of action, clinical efficacy, safety, and costs of Alyftrek [V/T/D] shortly after its approval as therapy of cystic fibrosis mentions that its efficacy and safety are similar to that of Trikafta [E/T/I], both having a boxed warning about drug induced liver injury and liver failure and that ALT or AST elevations arose in 9% of V/T/D treated patients vs 7% with E/T/I). 40053374

## OTHER REFERENCE LINKS

1. Recent References on Ivacaftor: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Ivacaftor+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Ivacaftor, Lumacaftor, Tezacaftor, Elexacaftor, Vanzacaftor: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ivacaftor+Lumacaftor+Tezacaftor+Elexacaftor)